# Durvalumab

## OVERVIEW

### Introduction

Durvalumab is a human monoclonal antibody to programmed cell death ligand 1 (PD-L1), which acts as a checkpoint inhibitor and is used in the immunotherapy of several forms of advanced or metastatic cancer. Durvalumab like other checkpoint inhibitors has major side effects and particularly immune related conditions, including acute hepatocellular and cholestatic liver injury which can be serious and even life threatening.

### Background

Durvalumab (dur val’ ue mab) is a human recombinant monoclonal IgG1 kappa-isotype antibody to the ligand for the programmed cell death receptor (PD-L1), which has distinctive immunomodulatory activity and is used as a checkpoint inhibitor in cancer immunotherapy. The programmed cell death receptor 1 (PD-1) is an important checkpoint molecule that is expressed on activated T and B cells. Binding of the ligand to PD-1 activates programmed cell death pathways that terminate or down regulate cytotoxic T cell responses. Monoclonal antibody binding to PD-L1 prevents its engagement with the PD-1 receptor and subsequent induction of the cellular pathways that down regulate T cell responses. Inhibition of this pathway allows for a continued activation and proliferation of cytotoxic T cells and proinflammatory cytokines. The enhancement of cytotoxic reactivity may play a beneficial role in cancer immunotherapy by breaking immunological tolerance to cancer cell neo-antigens. In several large multicenter studies, durvalumab therapy resulted in a prolongation of progression free survival in patients with advanced, metastatic or unresectable urothelial carcinoma. Durvalumab was granted accelerated approved for use in advanced urothelial cancer in the United States in 2017. This specific indication was withdrawn in 2021 when postmarketing trials failed to show improvement in survival with durvalumab therapy more than with conventional therapy. However, indications for durvalumab were expanded to include advanced, refractory non-small cell lung cancer (NSCLC) and extensive-stage small cell lung cancer (SCLC), and it continues to be evaluated as therapy of other advanced malignancies. Durvalumab is available as a solution in single use vials of 120 and 500 mg (50 mg/mL) under the brand name Imfinzi. The typical regimen is 10 mg/kg by intravenous infusion over 60 minutes every 2 weeks or 1500 mg every 4 weeks until disease progression or intolerance occurs.

As with most checkpoint inhibitors, side effects of durvalumab are common and can include fatigue, headache, musculoskeletal pain, arthralgia, abdominal pain, diarrhea, nausea, vomiting, decreased appetite, weight loss, fever, cough, dyspnea, pruritus, and rash. Importantly, as a result of the immune enhancement, between 15% and 25% of treated patients develop immune related side effects. These reactions are high grade in 10% of patients and can include enterocolitis, dermatitis, endocrinopathy, pneumonitis, neuropathy, nephritis and hepatitis. Most of these reactions respond to discontinuation and corticosteroid therapy, but some have resulted in fatalities and some have required permanent discontinuation of the checkpoint inhibitor and long term immunosuppressive therapy. Baseline screening and regular monitoring for these adverse events during durvalumab therapy is recommended. Early recognition and prompt management of side effects is an integral component of proper use of checkpoint inhibitors. Checkpoints inhibitors should be used only by health care professionals with training in immunotherapy and experience in the management of the side effects of immunomodulatory agents. Other rare but potentially severe adverse effects of durvalumab include infusion hypersensitivity reactions and embryo-fetal toxicity.

### Hepatotoxicity

Mild-to-moderate serum aminotransferase elevations are not uncommon (20% to 30%) during durvalumab therapy, but are usually self-limited and resolve even with continuing cyclic therapy. These rates of serum enzyme elevations are similar to those with other forms of chemotherapy for advanced malignancies. Serum ALT elevations above 5 times the upper limit of normal (ULN) occur in 1% to 4% of patients and generally lead to temporary or permanent discontinuation. Importantly, in 1% to 2% of treated patients the serum enzyme elevations evolve into an immune mediated liver injury that can be clinically apparent and can be severe. The onset of injury is typically after 2 to 4 cycles or 1 to 3 months after starting treatment. The pattern of enzyme elevation is usually hepatocellular but can be mixed or even cholestatic. Liver histology demonstrates a pan-lobular hepatitis with focal or confluent necrosis and prominent lymphocytic infiltrates of activated T cells, compatible with an immune mediated hepatic injury. More severe forms of hepatitis may demonstrate centrilobular (zone 3) necrosis. Despite features of immune mediated liver injury, autoantibodies are usually not present and immunoglobulin levels are typically normal. Because of the serious nature of the liver injury, monitoring with routine liver tests (including alkaline phosphatase) is recommended for patients who receive checkpoint inhibitor therapy. Treatment with corticosteroids generally results in a rapid improvement, allowing for their discontinuation within 1 to 2 months. In some instances, however, the clinical and biochemical response is inadequate, calling for addition of a second immunosuppressive agent such as azathioprine or mycophenolate mofetil. Restarting durvalumab or another checkpoint inhibitor after resolution of the hepatic injury is sometimes possible but can result in recurrence of injury and has not been shown to improve outcome of the cancer chemotherapy.

A proportion of patients receiving durvalumab develop cholestatic rather than hepatocellular liver injury. Cholestatic forms of immune mediated liver injury generally arise later than the hepatocellular forms (after 3 to 10 cycles) and are often accompanied by abdominal pain and jaundice. Alkaline phosphatase levels are markedly elevated while aminotransferase levels are only modestly increased. Imaging studies may show irregular dilatation of the intra- and/or extrahepatic bile ducts and thickening of the gall bladder and bile duct wall, but without evidence of frank obstruction. Liver biopsy shows portal inflammation and bile duct injury and endoscopic biopsy of the bile duct epithelium shows inflammation and scarring. The general features suggest a secondary form of sclerosing cholangitis or cholangiopathy. Therapy with immunosuppression may improve alkaline phosphatase and bilirubin levels but rarely leads to complete recovery, and long term cholestasis and hepatic failure can occur. Some patients with a cholestatic form of immune related hepatitis do not manifest the large bile duct changes but demonstrate loss and paucity of smaller intrahepatic bile ducts compatible with vanishing bile duct syndrome and similar to primary biliary cholangitis (PBC).

The effects of PD-L1 inhibition on chronic hepatitis B are not well defined but convincing examples of reactivation of hepatitis B have been described due to other checkpoint inhibitors. Most cases have occurred in patients with preexisting HBsAg, but rare instances were reported in individuals suspected of having with anti-HBc without HBsAg. Thus, screening patients for HBsAg, anti-HBc and anti-HBs is appropriate before initiating immunotherapy with checkpoint inhibitors. Patients with HBsAg should be considered for prophylaxis with an antiviral agent with potent activity against HBV such as entecavir or tenofovir. In patients with anti-HBc without HBsAg, monitoring and close attention to liver test abnormalities is probably adequate if antiviral therapy can be introduced rapidly for early evidence of reactivation. There has not been adequate experience with durvalumab in regard to the risk of reactivation of hepatitis B to provide rates of reactivation with and without antiviral prophylaxis.

Likelihood score: B (likely cause of clinically apparent, immune mediated liver injury and probable cause of reactivation of hepatitis).

### Mechanism of Injury

The liver injury due to durvalumab is likely immunologically mediated and is usually at least partially responsive to corticosteroid or immunosuppressive therapy. Liver biopsies in cases of hepatocellular injury and bile duct epithelial cell biopsies in cholangiopathic injury demonstrate necrosis and inflammatory cell infiltration with cytotoxic CD8+ T cells, suggesting that the checkpoint inhibition allowed for activation of T cells directed at hepatocyte or cholangiocyte cell surface antigens.

### Outcome and Management

Guidelines for management of patients receiving durvalumab recommend monitoring of liver tests and interrupting therapy for patients who develop serum aminotransferase elevations above 3 times the ULN and discontinuing treatment for values above 8 times the ULN in patients without pre-existing abnormalities or tumor involvement of the liver [in whom elevations of 5 and 10 times the ULN are used]. Corticosteroid therapy can be considered for patients with high or persistent ALT elevations or if symptoms or jaundice arise, initiating therapy with high dose intravenous methylprednisolone and switching to oral prednisone after 1 to 2 days, continuing tapering doses for at least 30 days.

Most cases of hepatitis due to checkpoint inhibitors resolve with prompt institution of immunosuppressive therapy which can be discontinued in 1 to 3 months. In some cases, adding a second agent (such as mycophenolate mofetil, azathioprine, antithymocyte globulin, infliximab or tacrolimus) and prolonged immunosuppression may be necessary. The few fatal cases that have been reported during immunotherapy with checkpoint inhibitors occurred in patients who had other severe immune related adverse events (Stevens Johnson syndrome, capillary leak syndrome) or who had an immune-related cholangiopathy or severe acute hepatitis resistant to immunosuppressive therapy. Restarting durvalumab after severe liver injury requiring corticosteroid therapy can be followed by recurrence of liver injury and is not recommended. Switching to other checkpoint inhibitors (ipilimumab or anti-PD-1 inhibitors) is more likely to be tolerated. However, survival rates do not seem to be improved by re-introduction of checkpoint inhibitor therapy after severe immune related adverse events. Thus, restarting therapy should be undertaken only after careful evaluation of the residual cancer status.

Drug Class: Antineoplastic Agents, Monoclonal Antibodies, Checkpoint Inhibitors

## CASE REPORT

Case 1. Acute mixed liver injury due to durvalumab.(1)

A 77 year old woman with metastatic breast cancer developed elevations in serum enzymes after starting durvalumab therapy. She had no history of liver disease, and liver tests were normal before starting checkpoint inhibitor therapy. With the initial two infusions of durvalumab she was found to have mild to moderate serum ALT elevations (3 to 5 times ULN) one week later which resolved by the time of the next planned infusion (Table). The degree of aminotransferase elevations after infusions appeared to decline with the third and fourth infusions. At the time of the 6^th^ planned cycle, however, her aminotransferase and alkaline phosphatase levels were both markedly elevated (Table). Serum total bilirubin levels and INR were normal. Tests for hepatitis A, B and C were negative. Antinuclear and smooth muscle antibodies were negative. Abdominal ultrasound and CT scans showed no evidence of bile duct dilation or abnormalities. Liver biopsy was not done. She was started on high dose oral prednisone (1 mg/kg daily), which was followed by a slow improvement in enzymes, but worsening when prednisone doses were lowered. She was also found to be hypothyroid and was started on levothyroxine. After 3 months of corticosteroid therapy, azathioprine was added which allowed for discontinuation of prednisone. Six months after onset her liver tests were normal while on azathioprine alone. Checkpoint inhibitor therapy was not restarted. Subsequently, azathioprine was stopped and liver tests remained normal. She was treated with capecitabine and doxorubicin, but died of complications of advanced breast cancer 6 months later.

Key Points

Medication: | Durvalumab (1120 mg iv every 3 weeks)
Pattern: | Mixed initially (R=2.3), cholestatic thereafter (R=0.6 to 1.6)
Severity: | 1+ (liver enzyme elevations without jaundice)
Latency: | 4 months
Recovery: | 4-6 months
Other medications: | None mentioned

Laboratory Values

Days After Starting | Days After Stopping | ALT (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Comment
-21 | | 32 | 129 | 0.2
0 (1^st^ dose) | | 30 | 125 | 0.3 | Durvalumab started
7 | | 190 | 107 | 0.4
21 (2^nd^ dose) | | 38 | 120 | 0.4
28 | | 112 | 114 | 0.3
42 (3^rd^ dose) | | 25 | 99 | 0.4
49 | | 43 | 86 | 0.3
63 (4^th^ dose) | | 17 | 98 | 0.3
70 | | 41 | 109 | 0.4
84 (5^th^ dose) | | 26 | 105 | 0.4
91 | | 33 | 89 | 0.4
105 (dose held) | 0 | 417 | 511 | 0.6 | Prednisone (1 mg/kg)
114 | 9 | 86 | 293 | 0.4 | Prednisone taper
119 | 14 | 54 | 245 | 0.4
126 | 21 | 70 | 244 | 0.4
133 | 28 | 165 | 312 | 0.4
140 | 35 | 267 | 713 | 0.3 | Prednisone dose increase
162 | 57 | 67 | 499 | 0.6
176 | 71 | 34 | 109 | 1.2 | Azathioprine added
232 | 127 | 51 | 61 | 1.4 | Prednisone stopped
301 | 196 | 39 | 72 | 0.7
Normal Values | | <45 | <130 | <1.2

Comment

The mild-to-moderate and transient elevations of ALT after initial infusions of durvalumab represent the well known frequent ALT elevations that occur during checkpoint inhibitor therapy. Following 5 cycles, however, more substantial and persistent elevations of both ALT and alkaline phosphatase occurred and immunosuppressive therapy with corticosteroids was started. The liver injury was cholestatic but there was no evidence of bile duct dilation or cholangiopathy. Ultimately, prednisone was stopped and she was maintained on azathioprine alone. While checkpoint inhibitor liver injury has been described as usually hepatocellular and monitoring for ALT and AST are recommended, cholestatic cases with prominent elevations in alkaline phosphatase such as in this case occur and are typically more resistant to immunosuppressive therapy.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Durvalumab – Imfinzi®

DRUG CLASS

Antineoplastic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Durvalumab)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Durvalumab | 1428935-60-7 | Monoclonal Antibody | Not Available

## CITED REFERENCE

1 Fontana RJ, Hayashi PH, Barnhart H, Stolz A, Odin J, Gu S, Drug Induced Liver Injury Network. (2020). Checkpoint inhibitor hepatotoxicity is characterized by peripheral eosinophilia and hepatocellular or mixed injury at onset but a low risk of liver failure during follow up. Hepatology.

## ANNOTATED BIBLIOGRAPHY

References updated: 23 June 2022

Abbreviations used: CPI, checkpoint inhibitor; CTLA-4, cytotoxic T lymphocyte associated antigen 4; HCC, hepatocellular carcinoma; irAE, immune related adverse event; PD-1, programmed cell death receptor 1; PD-L1, programmed cell death receptor ligand-1; NSCLC, non-small cell lung cancer; SCLC, small cell lung cancer.

Wellstein A, Giaccone G, Atkins MB, Sausville EA. Pathway-targeted therapies: monoclonal antibodies, protein kinase inhibitors, and various small molecules. In, Brunton LL, Hilal-Danan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 1203-36. (Textbook of pharmacology and therapeutics).
FDA. https://www.accessdata.fda.gov/drugsatfda_docs/nda/2017/761069Orig1s000MedR.pdf (FDA website with current and previous product labels and the initial 2017 medical review of the New Drug Application for durvalumab; ALT elevations above 5 times ULN arose in 1% and Alk P elevations in 4% of recipients; includes descriptions of cases of immune mediated hepatitis, one of which was fatal: pages 74-9).
Phan GQ, Yang JC, Sherry RM, Hwu P, Topalian SL, Schwartzentruber DJ, Restifo NP, et al. (2003). Cancer regression and autoimmunity induced by cytotoxic T lymphocyte-associated antigen 4 blockade in patients with metastatic melanoma. Proc Natl Acad Sci U S A. (Initial study of anti-CTLA-4 therapy in 14 patients with melanoma, 6 of whom developed clinically apparent immune adverse reactions including one with hepatitis arising after the third infusion [ALT 6820 U/L], resolving over the ensuing 4 months with corticosteroid therapy: Case 1, ipilimumab).
Kleiner DE, Berman D. (2012). Pathologic changes in ipilimumab-related hepatitis in patients with metastatic melanoma. Dig Dis Sci. (Clinical and histological features of 5 patients with acute liver injury due to ipilimumab [anti-CTLA-4]; 3 men and 2 women, ages 43 to 76 years, arising after 2-4 courses, 39-71 days after initial dose [peak bilirubin 1.5-5.1 mg/dL, ALT 326-3070 U/L, Alk P 206-427 U/L], only one had autoantibodies, resolving with immunosuppressive therapy within 1-4 months; one had recurrence on rechallenge; liver biopsies showed acute hepatitis usually with prominent inflammation, interface hepatitis and confluent necrosis: Case 1 Ipilimumab).
Topalian SL, Hodi FS, Brahmer JR, Gettinger SN, Smith DC, McDermott DF, Powderly JD, et al. (2012). Safety, activity, and immune correlates of anti-PD-1 antibody in cancer. N Engl J Med. (Among 296 patients with advanced cancers [melanoma, NSCLC, renal, prostate and colorectal] treated with 1 of 5 doses of nivolumab every 2 weeks, response rates were highest with melanoma and renal cancer, and drug related adverse events were common, including immune related conditions such as pneumonitis [3 fatal], vitiligo, colitis, hepatitis [reversible in all cases], hypophysitis and thyroiditis; ALT elevations occurred in 11 patients [4%] and were greater than 5 times ULN in 2 [1%]).
Teply BA, Lipson EJ. (2014). Identification and management of toxicities from immune checkpoint-blocking drugs. Oncology (Williston Park). (Clinical review of the toxicities of immune checkpoint blocking drugs such as ipilimumab, pembrolizumab and nivolumab; mentions that elevations of serum aminotransferase elevations should lead to careful exclusion of other causes of liver injury and increased monitoring; that elevations above 3 times ULN should lead to withholding the drug and starting corticosteroids; that elevations above 5 times ULN should lead to hospital admission and immediate administration of high doses of corticosteroids).
Tumeh PC, Harview CL, Yearley JH, Shintaku IP, Taylor EJ, Robert L, Chmielowski B, et al. (2014). PD-1 blockade induces responses by inhibiting adaptive immune resistance. Nature. (Analysis of expression of PD-1 and its ligand on CD8+ T cells at the margins of melanoma tumors before and after treatment with pembrolizumab showed that high levels of PD-1 and its ligand are found in responders to therapy).
Sharma P, Allison JP. (2015). The future of immune checkpoint therapy. Science. (Commentary and review of the rationale, history, clinical efficacy and mechanism of action of immune checkpoint therapy).
Abdel-Rahman O, El Halawani H, Fouad M. (2015). Risk of elevated transaminases in cancer patients treated with immune checkpoint inhibitors: a meta-analysis. Expert Opin Drug Saf. (Analysis of publications on checkpoint inhibitors indicated that therapy was associated with higher rates of ALT elevations).
Davar D, Wilson M, Pruckner C, Kirkwood JM. (2015). PD-1 blockade in advanced melanoma in patients with hepatitis C and/or HIV. Case Rep Oncol Med. (59 year old woman and 47 year old man with metastatic melanoma and combined HIV and hepatitis C infection were treated with pembrolizumab, tolerating therapy with no worsening of liver disease or HIV infection).
Syed YY. (2017). Durvalumab: First global approval. Drugs. (Review of the mechanism of action, pharmacology, clinical efficacy and safety of durvalumab shortly after its approval for use in metastatic urothelial carcinoma in the US; mentions that liver injury occurred in 3.3% of patients and fatalities of acute liver injury have occurred).
(2017). Three drugs approved for urothelial carcinoma by FDA. Cancer Discov. (News report on the approval of 3 new checkpoint inhibitors for therapy of advanced or metastatic urothelial carcinoma in patients whose disease has advanced despite treatment with platinum-containing chemotherapies: pembrolizumab [anti-PD-1], avelumab [anti-PD-L1] and durvalumab [anti-PD-L1]).
Massard C, Gordon MS, Sharma S, Rafi S, Wainberg ZA, Luke J, et al. (2016). Safety and efficacy of durvalumab (MED 14736), an anti-programmed cell death ligand-1 immune checkpoint inhibitor, in patients with advanced urothelial bladder cancer. J Clin Oncol. (Among 41 patients with advanced, refractory urothelial bladder cancer treated with durvalumab for up to 12 months, the objective response rate was 31% and adverse event rate 64%; most frequently fatigue [13%], diarrhea [10%] and anorexia [8%]; no mention of ALT elevations or hepatotoxicity).
Antonia S, Goldberg SB, Balmanoukian A, Chaft JE, Sanborn RE, Gupta A, Narwal R, et al. (2016). Safety and antitumour activity of durvalumab plus tremelimumab in non-small cell lung cancer: a multicentre, phase 1b study. Lancet Oncol. (Among 102 patients with refractory NSCLC treated with various doses of durvalumab [anti-PD-L1] and tremelimumab [anti-CTLA-4], side effects were common leading to discontinuations in 28% and ALT elevations in 0% to 12% of regimens).
Antonia SJ, Villegas A, Daniel D, Vicente D, Murakami S, Hui R, Yokoi T, et al. (2017). PACIFIC Investigators. Durvalumab after chemoradiotherapy in Stage III non-small-cell lung cancer. N Engl J Med. (Among 709 patients with NSCLC treated with durvalumab [10 mg/kg] or placebo intravenously every two weeks for up to 12 months after chemoradiotherapy, the mean progression-free survival was 16.8 vs 5.6 months and immune related adverse events occurred in 24% vs 8%, most commonly pneumonitis and thyroid dysfunction; no mention of immune related liver adverse events).
Santini FC, Rizvi H, Plodkowski AJ, Ni A, Lacouture ME, Gambarin-Gelwan M, Wilkins O, et al. (2018). Safety and efficacy of re-treating with immunotherapy after immune-related adverse events in patients with NSCLC. Cancer Immunol Res. (Among 482 patients with metastatic or advanced NSCLC treated with checkpoint inhibitors at a single US referral center between 2011 and 2016, 68 [14%] developed a serious immune related adverse event [irAE] that required discontinuation, and when 38 were retreated, 18 had no recurrence, 10 had recurrence of the same immune related event, 10 had a new one [2 of which were fatal]; restarting therapy appeared to be beneficial only in those without a tumor response before onset of the event).
Huffman BM, Kottschade LA, Kamath PS, Markovic SN. (2018). Hepatotoxicity after immune checkpoint inhibitor therapy in melanoma: natural progression and management. Am J Clin Oncol. (Among 281 patients with cancer treated with checkpoint inhibitors at the Mayo Clinic over a 5 year period, 17 [6%] developed liver injury within 16-151 [median=52] days of starting [ipilimumab alone in 12, with nivolumab in 2 and pembrolizumab alone in 3], all with ALT elevations [59 to 2355 U/L], often with Alk P elevations [up to 1728 U/L], 6 with jaundice [bilirubin 2.5 to 15.7 mg/dL], all but one treated with corticosteroids, responding in 6-56 [median 31] days, 2 requiring a second agent [azathioprine or cycloserine], none fatal).
Postow MA, Sidlow R, Hellmann MD. (2018). Immune-related adverse events associated with immune checkpoint blockade. N Engl J Med. (Review of the clinical features, outcomes, pathogenesis and therapy of immune related adverse events of checkpoint inhibitor therapy).
De Martin E, Michot JM, Papouin B, Champiat S, Mateus C, Lambotte O, Roche B, et al. (2018). Characterization of liver injury induced by cancer immunotherapy using immune checkpoint inhibitors. J Hepatol. (Among 536 patients treated with checkpoint inhibitors, 19 [3.5%] were referred to a liver service for high grade hepatitis and 16 underwent liver biopsy; ages 33 to 84 years, 56% female, injury arising after 1-36 [median=5] weeks and after 1-36 [median=2] doses, 38% presenting with fever, 31% rash, with ALT 266 to 3137 [460] U/L, Alk P 54 to 768 [309] U/L, bilirubin 0.4 to 19 [1.1] mg/dL, enzyme pattern mostly mixed, 10 given corticosteroids, 6 resolving spontaneously, no deaths).
Jennings JJ, Mandaliya R, Nakshabandi A, Lewis JH. (2019). Hepatotoxicity induced by immune checkpoint inhibitors: a comprehensive review including current and alternative management strategies. Expert Opin Drug Metab Toxicol. (Comprehensive review of the clinical features, diagnosis, histology, outcomes and management of checkpoint inhibitor related liver injury including serum aminotransferase elevations and immune related hepatic injury, with recommendations on use of corticosteroids based upon the grade of liver injury).
Abu-Sbeih H, Tran CN, Ge PS, Bhutani MS, Alasadi M, Naing A, Jazaeri AA, et al. (2019). Case series of cancer patients who developed cholecystitis related to immune checkpoint inhibitor treatment. J Immunother Cancer. (Among 4253 patients treated with checkpoint inhibitors at the MD Anderson Cancer Center between 2010 and 2018, 25 [0.6%] developed acalculous cholecystitis attributed to the immunotherapy most frequently with anti-CTLA-4 agents alone [1.6%], than with anti-PD-1/PD-L1 [0.4%] or combination [0.9%], mean age was 60 years, 60% male, 64% white, median peak ALT 55 U/L, bilirubin 1.4 mg/dL, 20% underwent cholecystectomy, all recovered, 10 [40%] restarted therapy, all without recurrence).
Fouchard M, Jantzem H, Quere G, Descourt R, Robinet G, Poureau PG. (2019). Three cases of immune cholangitis related to anti-programmed cell death and programmed cell death ligand agents for the treatment of non-small cell lung cancer. Eur J Cancer. (3 patients with metastatic lung cancer developed cholangitis 2, 4 and 9 months after starting checkpoint inhibitor therapy [nivolumab, durvalumab/tremelimumab, pembrolizumab] presenting with abdominal pain and fever, modest ALT but marked Alk P elevations and minimal jaundice; imaging showing biliary dilation and thickening of the gallbladder wall, biopsies showing inflammation with CD8+ lymphocytes, and slow clinical response to corticosteroids but long term remission in cancer).
Zen Y, Chen YY, Jeng YM, Tsai HW, Yeh MM. (2020). Immune-related adverse reactions in the hepatobiliary system: second-generation check-point inhibitors highlight diverse histological changes. Histopathology. (Description of 10 cases of second generation checkpoint inhibitor induced immune liver injury mentions 3 patterns, hepatocellular, cholestatic and granulomatous injury, the cholestatic form often with a delayed latency and poor response to corticosteroids).
Cheung V, Gupta T, Payne M, Middleton MR, Collier JD, Simmons A, Klenerman P, et al. (2019). Immunotherapy-related hepatitis: real-world experience from a tertiary centre. Frontline Gastroenterol. (Among 453 patients treated with checkpoint inhibitors for cancer between 2022 and 2018, 20 [4%] developed immune related hepatitis, with highest rates with the combination of ipilimumab and nivolumab, 18 treated with immunosuppression using corticosteroids, 8 with addition of mycophenolate and 2 with infliximab, none fatal).
Peeraphatdit TB, Wang J, Odenwald MA, Hu S, Hart J, Charlton MR. (2020). Hepatotoxicity from immune checkpoint inhibitors: a systematic review and management recommendation. Hepatology. (Review of the clinical features, biochemical findings, histology, pathogenesis, diagnosis and management of immune related liver injury due to the checkpoint inhibitors).
Mizuno K, Ito T, Ishigami M, Ishizu Y, Kuzuya T, Honda T, Kawashima H, et al. (2020). Real world data of liver injury induced by immune checkpoint inhibitors in Japanese patients with advanced malignancies. J Gastroenterol. (Among 546 patients with advanced malignancies treated with checkpoint inhibitors at two Japanese referral centers between 2014 and 2019, high grade, immune mediated liver injury occurred in 29 [5%], mean age 69 years, 73% male, mean onset 52 [range 1-273] days, after 3 [1-15] doses of ipilimumab [6%], nivolumab [54%], pembrolizumab [30%], atezolizumab [6%], durvalumab [2.4%], combination [1.3%], presenting with hepatocellular [21%], cholestatic [59%] or mixed [21%] enzyme elevations, 4 with cholangitis and biliary dilatation without obstruction, only 1 case fatal; predictive factors for injury included ipilimumab [hazard ratio 4.2]).
Miller ED, Abu-Sbeih H, Styskel B, Nogueras Gonzalez GM, Blechacz B, Naing A, et al. (2020). Clinical characteristics and adverse impact of hepatotoxicity due to immune checkpoint inhibitors. Am J Gastroenterol. (Among 5762 recipients of checkpoint inhibitor therapy of cancer at the MD Anderson Cancer Center between 2010 and 2018, 433 [8%] developed ALT levels and 100 had levels above 5 times ULN [2%), the rate being 8% with combination therapy, 1.7% with anti-CTLA agents and 1.1% with PD-1 and PD-L1 blockers, the abnormalities arising after a median 59 days; all had the checkpoint inhibitor therapy held, 67 received corticosteroids [for a median of 43 days], 3 with mycophenolate, and 31 were rechallenged after resolution of the hepatitis, of whom 8 [26%] had a recurrence).
Vitale G, Lamberti G, Comito F, Di Nunno V, Massari F, Morelli MC, Ardizzoni A, et al. (2020). Anti-programmed cell death-1 and anti-programmed cell death ligand-1 immune-related liver diseases: from clinical pivotal studies to real-life experience. Expert Opin Biol Ther. (Review of the hepatic complications of anti-PD1 and anti-PD-L1 checkpoint inhibitors that includes immune mediated hepatitis [typically panlobular inflammation and injury], small and large duct cholangitis [similar to primary biliary and sclerosing cholangitis], immune mediated cholecystitis, nodular regenerative hyperplasia and vanishing bile duct syndrome).
Ruggiero R, Fraenza F, Scavone C, di Mauro G, Piscitelli R, Mascolo A, Ferrajolo C, et al. (2020). Immune checkpoint inhibitors and immune-related adverse drug reactions: data from Italian Pharmacovigilance Database. Front Pharmacol. (Among 2088 safety reports of check point inhibitors enrolled in an Italian pharmacovigilance registry, 801 were immune related including gastrointestinal [33%], skin [17%] and liver [2.7%] due to nivolumab [70%], pembrolizumab [11%], ipilimumab [15%], atezolizumab [4%] and avelumab [<1%]).
Nakamura M, Otsuka T, Hayashi R, Horita T, Ota M, Sakurai N, Takano H, et al. (2020). Durvalumab-induced immune-related hepatitis in a patient with non-small cell lung cancer. Intern Med. (79 year old man with NCSLC developed liver test abnormalities on day 208 of durvalumab maintenance therapy [bilirubin 1.0 mg/dL, ALT 1425 U/L, Alk P 757 U/L, INR normal], biopsy showing a panlobular hepatitis and liver tests falling into the normal range within a month of starting corticosteroid therapy).
Nakashima K, Demura Y, Oi M, Tabata M, Tada T, Shiozaki K, Akai M, et al. (2020). Infliximab was found to be effective for treating immunosuppressive drug-resistant hepatitis due to durvalumab. Intern Med. (69 year old man with squamous cell lung cancer developed jaundice 38 days after a single dose of durvalumab [bilirubin 7.5 mg/dL, ALT 337 U/L, Alk P 3196 U/L], with minimal improvement despite therapy with prednisolone, mycophenolate, azathioprine and tacrolimus, but prompt improvement with a first dose of infliximab, but Alk P remained above 1000 U/L 4 months later still on corticosteroids).
Powles T, van der Heijden MS, Castellano D, Galsky MD, Loriot Y, Petrylak DP, Ogawa O, et al., DANUBE study investigators. (2020). Durvalumab alone and durvalumab plus tremelimumab versus chemotherapy in previously untreated patients with unresectable, locally advanced or metastatic urothelial carcinoma (DANUBE): a randomised, open-label, multicentre, phase 3 trial. Lancet Oncol. (Among 1032 patients with advanced urothelial carcinoma treated with durvalumab [with or without tremelimumab] or conventional chemotherapy, survival was similar in the three groups, but high grade immune related adverse events were more common with durvalumab [6% and 17% vs <1%] and 2 of 345 treated with durvalumab alone died of liver failure [acute liver failure and progressive cholestasis]).
Goldman JW, Dvorkin M, Chen Y, Reinmuth N, Hotta K, Trukhin D, Statsenko G, et al., CASPIAN investigators. (2021). Durvalumab, with or without tremelimumab, plus platinum-etoposide versus platinum-etoposide alone in first-line treatment of extensive-stage small-cell lung cancer (CASPIAN): updated results from a randomised, controlled, open-label, phase 3 trial. Lancet Oncol. (Among 805 patients with advanced small-cell lung cancer treated with platinum-etoposide alone or with durvalumab with or without tremelimumab, median survival was slightly better with durvalumab alone [12.9 vs 10.4 and 10.5 months] while high grade immune related adverse events were more frequent [5% and 14% vs <1%] and 2 patients on durvalumab died of liver failure).
Mathieu L, Shah S, Pai-Scherf L, Larkins E, Vallejo J, Li X, Rodriguez L, et al. (2021). FDA approval summary: atezolizumab and durvalumab in combination with platinum-based chemotherapy in extensive stage small cell lung cancer. Oncologist. (FDA summary of data supporting approval of atezolizumab and durvalumab in combination with conventional platinum based chemotherapy for advanced small cell lung cancer, clinical trials demonstrating a slight increase in median survival [12.3 and 13.0 months vs 10.3 months] for both PD-L1 monoclonal checkpoint inhibitors compared to conventional chemotherapy alone).
Forde PM, Anagnostou V, Sun Z, Dahlberg SE, Kindler HL, Niknafs N, Purcell T, et al. (2021). Durvalumab with platinum-pemetrexed for unresectable pleural mesothelioma: survival, genomic and immunologic analyses from the phase 2 PrE0505 trial. Nat Med. (Among 55 patients with unresectable pleural mesothelioma treated with durvalumab, platinum and pemetrexed, median survival was 20.4 months [compared to 12 months in historical controls], and adverse events were usually mild, there were no high grade immune related adverse events and only one patient had mild and transient ALT elevations).
Godbert B, Petitpain N, Lopez A, Nisse YE, Gillet P. (2021). Hepatitis B reactivation and immune check point inhibitors. Dig Liver Dis. (67 year old man with metastatic lung cancer developed acute liver injury 21 days after a single dose of durvalumab [bilirubin 8.1 mg/dL, ALT 1168 U/L, GGT 847 U/L, HBsAg positive, HBV DNA 10 million IU/mL], with progressive hepatic failure and death 19 days later despite tenofovir therapy).
Wong GL, Wong VW, Hui VW, Yip TC, Tse YK, Liang LY, Lui RN, et al. (2021). Hepatitis flare during immunotherapy in patients with current or past hepatitis B virus infection. Am J Gastroenterol. (Among 990 patients in Hong Kong with advanced malignancies treated with checkpoint inhibitors between 2014 and 2019 [397 HBsAg positive, 482 with anti-HBc or anti-HBs, 111 negative for both at baseline], 39% of HBsAg-positive vs 30% of HBsAg-negative patients developed ALT elevations during therapy, but only two cases [both HBsAg positive and on prophylaxis] were due to HBV reactivation).
Mustafayev K, Torres H. Hepatitis B virus and hepatitis C virus reactivation in cancer patients receiving novel anticancer therapies. Clin Microbiol Infect. 2022:S1198-743X(22)00119-7. (Review of the literature on reactivation of HBV and HCV in patients on “novel” anticancer therapy concludes that reactivation can occur with checkpoint inhibitor therapy but largely among HBsAg positive patients and only rarely in patients with resolved hepatitis B).
Yoo S, Lee D, Shim JH, Kim KM, Lim YS, Lee HC, Yoo C, et al. (2022). Risk of hepatitis B virus reactivation in patients treated with immunotherapy for anti-cancer treatment. Clin Gastroenterol Hepatol. (Among 3,465 patients with advanced malignancies treated with checkpoint inhibitors between 2015 and 2020 at a single referral center in Korean, 511 [15%] were HBsAg positive at baseline, reactivation of HBV occurred in 5 of 511 [1%] HBsAg positive vs none of 2,954 HBsAg negative patients, arising in 2 of 464 [0.4%] patients given prophylaxis [both having stopped antivirals] vs 3 of 47 not given prophylaxis [6.4%]; reactivation arising after 3-141 weeks [median 54 weeks] of nivolumab [n=2], pembrolizumab [n=2] or ipilimumab and nivolumab [n=1] treatment, ALT peak 53 to 1768 IU/mL, HBV DNA 6,100 to 3.9 million IU/mL, resolving with 2 to 6 weeks of starting antiviral therapy).
Schoenfeld JD, Giobbie-Hurder A, Ranasinghe S, Kao KZ, Lako A, Tsuji J, Liu Y, et al. (2022). Durvalumab plus tremelimumab alone or in combination with low-dose or hypofractionated radiotherapy in metastatic non-small-cell lung cancer refractory to previous PD(L)-1 therapy: an open-label, multicentre, randomised, phase 2 trial. Lancet Oncol. (Among 90 patients with NSCLC resistant to anti-PD-1 or anti-PD-L1 therapy who were treated with durvalumab combined with tremelimumab or low dose radiation, the objective response rate was 11% and 8% and the adverse event rate was 76% but only one patient had mild, transient ALT elevations).
Avrillon V, Daniel C, Boisselier P, Le Péchoux C, Chouaid C. (2022). Nationwide real-life safety and treatment exposure data on durvalumab after concurrent chemoradiotherapy in unresectable stage III, locally advanced, non-small cell lung cancer: analysis of patients enrolled in the French early access program. Lung. (Among 576 patients with advanced NSCLC treated with durvalumab at 188 French referral centers, the adverse event rate was 64% including serious events in 12%, 4 cases of which were hepatobiliary, but there were no liver related deaths).
Naidoo J, Vansteenkiste JF, Faivre-Finn C, Özgüroğlu M, Murakami S, Hui R, Quantin X, et al. (2022). Characterizing immune-mediated adverse events with durvalumab in patients with unresectable stage III NSCLC: A post-hoc analysis of the PACIFIC trial. Lung Cancer. (Reanalysis of the PACIFIC trial of durvalumab in NSCLC found immune related adverse events in 20.1% [9.4% pneumonitis], which were high grade in 3.6% [1.9% pneumonitis] with only 2 patients with liver related immune mediated events [ALT elevation]).
Spigel DR, Faivre-Finn C, Gray JE, Vicente D, Planchard D, Paz-Ares L, Vansteenkiste JF, et al. (2022). Five-year survival outcomes from the PACIFIC Trial: Durvalumab After Chemoradiotherapy in Stage III Non-Small-Cell Lung Cancer. J Clin Oncol. (Follow up of patients with advanced NSCLC treated enrolled in the PACIFIC trial of adjuvant therapy found the overall 5-year estimated survival to be 43% for durvalumab vs 33% for placebo, a similar difference to what was found at 1 and 3 years; no further information on liver injury or its consequences).
Park S, Noh JM, Choi YL, Chi SA, Kim K, Jung HA, Lee SH, et al. (2022). Durvalumab with chemoradiotherapy for limited-stage small-cell lung cancer. Eur J Cancer. (Among 50 patients with small cell lung cancer treated with four 3-week cycles of etoposide, cisplatin and durvalumab, the 24 month progression-free survival was 42% and adverse events included one case of high grade immune related hepatitis that resolved with corticosteroid therapy).
Ueno M, Takabatake H, Hata A, Kayahara T, Morimoto Y, Notohara K, Mizuno M. Mycophenolate mofetil for immune checkpoint inhibitor-related hepatotoxicity relapsing during dose reduction of corticosteroid: a report of two cases and literature review. Cancer Rep (Hoboken). 2022 May 16:e1624. Epub ahead of print. (Two men, ages 74 and 46 years, with advanced or metastatic lung cancer developed immune related pneumonitis and hepatitis after a 2^nd^ and a 1^st^ cycle of chemotherapy with durvalumab, responding partially to high doses of prednisolone but relapsing with lower doses, and then responding more completely with addition of mycophenolate mofetil [2000 mg/daily]).

## OTHER REFERENCE LINKS

1 Recent References on Durvalumab: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Durvalumab+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Durvalumab: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Durvalumab)